# Methyldopa

## OVERVIEW

### Introduction

Methyldopa (alpha-methyldopa or α-methyldopa) is a centrally active sympatholytic agent that has been used for more than 50 years for the treatment of hypertension. Methyldopa has been clearly linked to instances of acute and chronic liver injury that can be severe and even fatal.

### Background

Methyldopa (meth" il doe' pa) is a centrally active sympatholytic agent that reduces sympathic drive to the heart and peripheral circulation, leading to decreased cardiac output and lowered peripheral arterial resistance. Introduced in 1960, methyldopa rapidly became a leading antihypertensive agent, but in the last two decades its use has decreased markedly, replaced by better tolerated and more effective antihypertensive medications. Currently, the major use of methyldopa is treatment of hypertension during pregnancy, a use based upon its established record of safety during pregnancy and breast feeding. Methyldopa is available generically and formerly under the trade name Aldomet as 125, 250 and 500 mg tablets. Fixed combinations with hydrochlorothiazide are also available (Aldoril). The recommended maintenance dose in adults is 500 mg to 2 g daily in 2-4 divided doses. Common side effects include nausea, diarrhea, headache, dizziness, sedation, dry mouth and rash. Rare but potentially severe adverse effects include hemolytic anemia (Coombs positive), lupus-like syndrome, mycocarditis, pancreatitis and hepatotoxicity.

### Hepatotoxicity

Drug induced liver injury due to methyldopa was identified shortly after its introduction into medical use in the 1960’s. Chronic use of methyldopa is associated with mild and transient elevations in serum aminotransferase levels in 5% to 35% of patients, these elevations often resolving despite continuation of the medication. In contrast, clinically apparent or significant liver injury from methyldopa is relatively uncommon, although several hundred cases have been reported. Two patterns of hepatotoxicity have been described: an acute hepatitis that appears within weeks to months of starting treatment, and a chronic hepatitis that arises months to years after initiation of methyldopa therapy.

The acute liver injury from methyldopa generally arises within 2 to 12 weeks of starting therapy and is typically hepatocellular with marked elevations in ALT and AST (5- to 100-fold) and modest increases in alkaline phosphatase, although in a small proportion of patients the pattern of enzyme elevations is mixed or cholestatic (Case 1 and 2). Most patients become jaundiced. Symptoms resemble those of acute viral hepatitis, including fever, headache, fatigue, anorexia and nausea. Signs of hypersensitivity other than fever are uncommon. The injury can be severe and fatal. While some cases are associated with marked cholestasis and prolonged jaundice, most patients recover within 4 to 12 weeks. Autoantibodies including Coombs and antinuclear antibody positivity may be present (but also can arise independent of liver injury). Liver biopsy shows an acute hepatitis-like picture with marked inflammatory infiltrates and fatty change, with variable amounts of necrosis. Rechallenge leads to rapid recurrence of liver injury and can result in severe hepatitis, acute liver failure and death.

The chronic liver injury from methyldopa usually arises after 6 months, but may become first evident after several years of therapy (Case 3). This chronic hepatitis-like clinical picture has a more insidious onset typically with fatigue, weakness and nausea associated with mild or no jaundice. Clinical features may include liver enlargement and tenderness and spider angiomata. The clinical and laboratory pattern often resembles autoimmune hepatitis, with moderate to marked elevations in ALT and AST, modest alkaline phosphatase elevations, increases in immunoglobulin levels (particularly IgG), and high titers of autoantibodies such as antinuclear antibody (ANA) and smooth muscle antibody (SMA). Liver biopsy demonstrates findings of chronic active hepatitis with variable amounts of fatty change and fibrosis. Plasma cell infiltrates may be prominent. Cirrhosis and end stage liver disease can occur if the drug is continued. The disease resolves slowly but completely with discontinuation of methyldopa. Chronic liver injury now appears to be the most common form of drug induced liver injury from this agent. Some cases of methyldopa induced liver injury have features of both acute and chronic injury and the two forms of hepatic injury may share a common etiology.

African Americans appear to have a higher risk for liver injury from methyldopa than Caucasians or Hispanic individuals. The course may be more severe and outcome less favorable in Africans Americans as well. Granulomatous hepatitis can also occur with methyldopa therapy, usually in association with drug fever and systemic symptoms (and granulomas elsewhere), and sometimes with granulomatous myocarditis which can be fatal. In these situations, the liver injury is usually mild and anicteric.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Hepatotoxicity

Both the acute and chronic hepatic injury from methyldopa have features that suggest an immune etiology, although less allergic than autoimmune in character. These findings and metabolic studies suggest that methyldopa may induce an autoimmune liver injury (perhaps via a toxic metabolic intermediate serving as an antigenic hapten presented on the surface of hepatocytes) in susceptible hosts.

### Outcome and Management

Both the acute and the chronic forms of liver injury from methyldopa can be severe, particularly if the medication is continued despite appearance of clinically significant injury. Recovery usually occurs within 6 to 8 weeks, but patients with chronic hepatitis can be left with inactive cirrhosis. Methyldopa ranks as one of the ten most common causes of acute liver failure due to medications, although its frequency is decreasing as its use has become more restricted. Because of its cost, methyldopa is still used widely for treatment of hypertension in developing nations, where cases of liver injury are likely to continue to arise. Patients with methyldopa induced liver injury should not be reexposed to this medication, but there is no evidence that there is cross susceptibility to liver injury with other antihypertensive agents. Prednisone has been used to treat both the acute and the chronic injury from methyldopa with unclear benefit. Management should focus on early withdrawal of methyldopa, and treatment with corticosteroids should be restricted only to severe or persistent cases and withdrawn in a timely manner.

Drug Class: Antihypertensive Agents

## CASE REPORTS

### Case 1. Abnormal serum aminotransferase levels developing during methyldopa therapy.(1)

A 29 year old woman was found to have hypertension during the first trimester of her first pregnancy and was started on methyldopa in a dose of 500 mg twice daily. Eight weeks later, during a routine prenatal visit, she was found to have elevations in serum aminotransferase levels. She was without symptoms of liver disease and denied all previous history of hepatitis or jaundice and any exposures or high risk behaviors. Serum alkaline phosphatase levels were minimally elevated and bilirubin, albumin and prothrombin time were normal. An abdominal ultrasound showed no abnormality of the liver or bile ducts. Serum ANA was positive in a titer of 1:160. She also had equivocal tests for anti-HCV and VDRL, both of which were later shown to be false positives. Methyldopa was stopped and her liver tests were normal one month later.

#### Key Points

Medication: | Methyldopa
Pattern: | Hepatocellular (R=28)
Severity: | 1+ (no jaundice)
Latency: | 8 weeks
Recovery: | Complete within 1 month
Other medications: | Nifedipine, multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 20 | 57 | 0.6 | Hypertensive
Methyldopa started
8 weeks | 0 | 800 | 125 | 0.5
8 weeks | 1 day | 442 | 125
| 3 days | 327 | 109
| 4 days | 296 | ..
9 weeks | 9 days | 87 | 94 | 0.7
10 weeks | 2 weeks | 20 | ..
12 weeks | 1 month | 30 | 57
10 months | 6 months | 13 | 51 | 0.7
Normal Values | | <45 | <125 | <1.2

#### Comment

This case is typical of asymptomatic elevations in serum aminotransferase levels that can occur during methyldopa therapy. These were indentified on routine testing and not as a result of symptoms or specific monitoring for hepatotoxicity. Recovery was rapid. The co-occurrence of ANA positivity and false positive VDRL and anti-HCV reactivity was probably due to methyldopa induced immune activation and hyperglobulinemia.

### Case 2. Acute hepatitis due to methyldopa.(2)

A 55 year old woman had been treated for hypertension intermittently with methyldopa in the past and then developed jaundice and fatigue 7 days after it was restarted. She had no other significant past medical history, took no other medications, did not drink alcohol and had no risk factors for viral hepatitis or liver disease. On admission, she was jaundiced and serum bilirubin was 6.8 mg/dL (5.0 mg/dL direct), AST 858 U/L and alkaline phosphatase 214 U/L (Table). A liver biopsy was compatible with acute drug induced liver injury. Markers of hepatitis B were negative. Further study showed that she had elevations in IgG, IgA and IgM, and was positive for smooth muscle (SMA) and antinuclear (ANA) antibodies and had a positive direct Coombs test. She was not anemic. Methyldopa was stopped and she recovered clinically quite rapidly; but biochemical and immunological abnormalities resolved only slowly over the next few months. Ultimately most abnormalities fell to normal or near normal, although SMA persisted in unchanging titers.

#### Key Points

Medication: | Methyldopa
Pattern: | Hepatocellular (R=8.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 week (prior exposure)
Recovery: | Complete by 6 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Methyldopa, which had been used intermittently for at least a year, was given for 7 days
1 week | 0 | 858 | 214 | 6.8
| 1 month | 300 | 140 | 1.6 | SMA+, ANA+, Coombs+
| 3 months | 100 | 95 | 0.8 | IgG 2300, IgA 600, IgM 300 mg/dL
| 5 months | 78 | 09 | | SMA+, ANA-, Coombs-
| 6 months | 63 | 88
| 7 months | 47 | 90 | | IgG 1300, IgA 250, IgM 78 mg/dL
Normal Values | | <40 | <86 | <1.2

#### Comment

Although the latency period was very short, this case was otherwise typical of the acute hepatocellular injury caused by methyldopa. Aminotransferase levels were more than 20-fold elevated while alkaline phosphatase was minimally increased. Autoantibodies and hypergammaglobulinemia can develop with methyldopa induced liver disease and give a clinical picture that resembles an acute onset of autoimmune hepatitis. However, in this case, the disease improved with discontinuation of methyldopa and the autoantibodies and elevated immunoglobulin levels ultimately improved once the liver injury had settled. Nevertheless, the minor abnormalities of serum enzymes many months after the injury are a good reason to continue to follow the patient for evidence of an underlying liver disease. She should be cautioned against receiving methyldopa again.

### Case 3. Chronic hepatitis caused by long term methyldopa therapy.(1)

A 25 year old woman developed signs and symptoms of chronic liver disease after 8 months of therapy with methyldopa. Methyldopa had been started in a dose of 250 mg twice daily during a pregnancy, but was then continued after she had a Caesarian section 3 months later. After being on methyldopa for 8 months, she had the insidious onset of nausea, dark urine, itching and jaundice. She was admitted to a local hospital and laboratory testing showed an ALT of 1292 U/L and bilirubin of 7.3 mg/dL. Tests for hepatitis A, B and C were negative. Both smooth muscle and antinuclear antibody were negative. CT scans and ultrasound of the liver were normal. A liver biopsy showed changes typical of chronic active hepatitis. Methyldopa was stopped, and she was placed on prednisone. Serum aminotransferases slowly improved. Six months later prednisone was stopped and in follow up her liver tests remained normal.

#### Key Points

Medication: | Methyldopa
Pattern: | Hepatocellular (R=21)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 8 months
Recovery: | Complete after 6 month course of prednisone
Other medications: | Triamterene

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Methyldopa started during pregnancy
8 months | 0 | 1292 | 126 | 10.3 | Methyldopa stopped
| 1 week | 1053 | 101 | 19.3
| 2 weeks | 1140 | 156 | 24.9 | Prednisone started
9 months | 4 weeks | 362 | 169 | 11.9
| 6 weeks | 88 | 102 | 3.0
10 months | 8 weeks | 64 | 113 | 2.0
11 months | 3 months | 80 | 61 | 1.0 | Prednisone tapered
12 months | 4 months | 45 | 74 | 1.0
14 months | 6 months | 29 | 69 | 0.5 | Prednisone stopped
20 months | 12 months | 19 | 83 | 1.0
Normal Values | | <60 | <126 | <1.2

#### Comment

This case represents an example of severe chronic active hepatitis induced by methyldopa. The use of prednisone is controversial, but the height of the bilirubin and ALT elevation led to its use. Importantly, once jaundice had resolved, the prednisone was withdrawn gradually and, in follow up, this patient was asymptomatic and had normal liver tests. Many cases of methyldopa induced acute and chronic hepatitis are accompanied by high levels of autoantibodies and immunoglobulin elevations. Comparison of cases with and without these autoimmune features, however, show little difference in clinical features, severity of injury, hepatic histology or outcome, suggesting that they are similarly immune mediated and that the autoantibodies do not play a pathogenetic role.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methyldopa – Generic, Aldomet® (Currently discontinued)

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Methyldopa)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Methyldopa | 555-30-6 | C10-H13-N-O4

## CITED REFERENCES

1 Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology.
2 Delpre G, Grinblat J, Kadish U, Livni E, Shoha B. Case report. Immunological studies in a case of hepatitis following methyldopa administration. Am J Med Sci 1979; 277: 207-13. PMID:37733

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd edition. Philadelphia: Lippincott Williams & Wilkins, 1999. pp. 656-8. (Expert review of methyldopa induced liver injury from 1999. At least 150 instances of hepatoxicity from methyldopa have been described; usually a hepatocellular pattern of injury and can present as a chronic hepatitis; rash and esoinophilia are rare, but ANA is often present).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-5. (Review of hepatotoxicity of antihypertensive agents mentions that hepatotoxicity from methyldopa resembles acute viral hepatitis and the toxicity appears to be immune mediated).
Eschenhagen T. Treatment of hypertension. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 507-26. (Textbook of pharmacology and therapeutics).
Gillespie L, Oates JA, Crout JR, Sjoerdsma A. (1962). Clinical and chemical studies with alpha-methyl-dopa in patients with hypertension. Circulation. (Review of 80 patients treated with methyldopa; 2 developed fever with accompanying abnormal AST and bilirubin levels, with rapid resolution upon stopping).
Williams ER, Khan MA. (1967). Liver damage in patients on methyldopa. J Ther Clin Res. (Summarized in Tysell et al. [1971]: two cases of liver injury appearing after 2 and 18 months of methyldopa therapy, with hepatocellular injury and jaundice).
Zarday Z, Rosenthal WS, Wolff FW. (1967). Severe liver toxicity after methyldopa. N Y State J Med. (37 year old man developed jaundice 2-3 months after starting methyldopa [bilirubin rising to 30.3 mg/dL, AST 1,120 U/L, Alk P 4 times ULN], worsening for 2 weeks after stopping before gradually resolving).
Elkington SG, Schreiber WM, Conn HO. (1969). Hepatic injury caused by L-alpha-methyldopa. Circulation. (37 year old man developed symptoms within 2 weeks of starting methyldopa, but it was continued for 4 months [biliubin 14.0 mg/dL, AST 1410 U/L, Alk P 3 times ULN], resolving after stopping and recurring in response to two rechallenges, but only after several weeks of exposure).
Eliastam M, Holmes AW. (1971). Hepatitis, arthritis and lupus cell phenomena caused by methyldopa. Am J Dig Dis. (40 year old man developed jaundice 2 months after starting methyldopa [bilirubin 7.4 mg/dL, ALT 1000 U/L, Alk P 2 times ULN] that began to resolve, but rapidly recurred upon reexposure for 2 weeks [bilirubin 5.1 mg/dL, ALT 1200 U/L, Alk P 2 times ULN], ultimately resolving).
Tysell JE, Knauer M. (1971). Hepatitis induced by methyldopa (aldomet). Report of a case and a review of the literature. Am J Dig Dis. (38 year old woman developed jaundice 2 months after starting methyldopa [bilirubin 6.1 mg/dL, ALT 1300 U/L, Alk P 3 times ULN], resolving spontaneously and recurring more rapidly [19 days] and severely [bilirubin 8.5 mg/dL, ALT 1240 U/L, Alk P 2 times ULN] on reexposure 3 years later).
Wong ML. (1971). Hepatocellular damage due to methyldopa. Med J Malaya.
Brouillard RP, Barret O. (1973). Methyldopa associated hepatitis. JAMA. (56 year old woman developed jaundice 41 days after starting methyldopa [bilirubin 15.0 mg/dL, AST 2070 U/L], recovering within 2 months of stopping).
Goldstein GB, Lam KC, Mistilis SP. (1973). Drug-induced active chronic hepatitis. Am J Dig Dis. (Among 21 cases of "active chronic hepatitis" presenting over a 1 year period, 9 were due to oxyphenisatin, 5 to methyldopa and 9 were idiopathic; methyldopa cases were all jaundiced and AST 200-600 U/L, latency averaged 15 months, all responded to corticosteroids; no mention of ANA).
Hoyumpa AM, Connell AM. (1973). Methyldopa hepatitis. Report of three cases. Am J Dig Dis. (Three women, ages 50-55 years, developed jaundice and acute hepatitis within 8-10 weeks of starting methyldopa, one case fatal and another protracted; severe recurrence with reexposure).
Rehman OU, Keith TA, Gall EA. (1973). Methyldopa-induced submassive hepatic necrosis. JAMA. (51 year old woman developed jaundice 3 months after starting methyldopa with recovery, but fatal recurrence upon reexposure).
Torres Gomez JM. (1973). Intrahepatic cholestasis due to alpha-methyldopa: a case report. Bol Asoc Med P R.
Hoffbrand BI, Fry W, Bunton GL. (1974). Cholestatic jaundice due to methyldopa. Br Med J. (51 year old woman developed jaundice and pruritus 2 months after starting methyldopa [bilirubin 11.3 mg/dL, AST and ALk P 2 times ULN, ANA negative], resolving slowly over 3 months after stopping).
Schweitzer IL, Peters RL. (1974). Acute submassive hepatic necrosis due to methyldopa. A case demonstrating possible initiation of chronic liver disease. Gastroenterology. (49 year old woman developed severe acute hepatitis 10 weeks after starting methyldopa [bilirubin 22.1 mg/dL, ALT 1860 U/L, Alk P 3 times ULN], with biopsy findings suggesting chronicity and Coombs and LE prep positivity; positive rechallenge [ALT 500 U/L after 8 days of reexposure] with 2 more biopsies).
Toghill PJ, Smith PG, Benton P, Brown RC, Matthews HL. (1974). Methyldopa liver damage. Br Med J. (Characterization of 20 cases of methyldopa induced liver injury; latency 2-32 weeks, most <6 weeks, all jaundiced, mostly hepatocellular or mixed, but two cholestatic, resolved with stopping; liver biopsies showing chronic active hepatitis in 2, acute liver failure in 2, cirrhosis in 2; severe recurrences with reexposure).
Toghill PJ, Smith PG, Benton P, Brown RC, Matthews HL. (1974). Proceedings: Liver damage in patients taking methyldopa. Gut. (Abstract summarizing 20 cases of methyldopa hepatotoxicity described in Toghill [1974]).
Maddrey WC, Boitnott JK. (1975). Severe hepatitis from methyldopa. Gastroenterology. (6 cases of methyldopa hepatotoxicity in 2 year period, all women, ages 38-62 years, onset of symptoms in 1-2 weeks, jaundice after 2-6 weeks; bilirubin 11.8-29.4 mg/dL, ALT 122-710 U/L, Alk P < twice ULN; 1 died; 2 had rash).
Sataline L, Lowell D. (1975). Delayed hepatotoxicity from methyldopa. Conn Med. (39 year old man developed acute hepatitis 3 years after starting methyldopa [bilirubin 6.8 mg/dL, AST 180 U/L, Alk P 188 U/L], resolving within 2 months of stopping).
Bonkowsky HL, Brisbane J. (1976). Colitis and hepatitis caused by methyldopa. JAMA. (55 year old man developed fever, rash, eosinophilia [11%], and diarrhea within 10 days of starting methyldopa [bilirubin 2.3 mg/dL, AST 150 U/L, Alk P 181 U/L], rapid improvement upon stopping, but immediate recurrence with single dose rechallenge).
Miller AC, Reid WM. (1976). Methyldopa-induced granulomatous hepatitis. JAMA. (49 year old woman developed fever, myalgias and nausea within 2 days of starting methyldopa, minimal AST and Alk P elevations; liver biopsy showed granulomas; not so much hepatotoxicity as drug-fever, with systemic granulomas).
Rodman JS, Deutsch DJ, Gutman SI. (1976). Methyldopa Hepatitis. A report of six cases and review of the literature. Am J Med. (Six cases of methyldopa hepatotoxicity, including 4 women and 2 men, 2 fatal, usually hepatocellular with latency of 4-12 weeks, resolution in 4-12 weeks, occasionally with Coombs positivity; review of 77 additional cases from the literature).
Thomas E. (1976). Methyldopa liver injury. J Assoc Physicians India.
Thomas E, Bhuta S, Rosenthal WS. (1976). Methyldopa-induced liver injury. Rapid progression to fatal postnecrotic cirrhosis. Arch Pathol Lab Med. (55 year old woman developed severe hepatitis 12 weeks after starting methyldopa [bilirubin 13.9 mg/dL, AST 900 U/L, Alk P 150 U/L], treated with corticosteroids, but developed subacute liver failure and death, not actually cirrhosis).
Puppala AR, Steinheber FU. Fulminant hepatic failure associated with methyldopa. Am J Gastroenterol 1977; 68: 578-81. PMID: 77129 (66 year old woman developed acute liver failure after 6 months of intermittent therapy with methyldopa, LE prepation positive, ANA negative).
Sakamaki H, Dan K, Onozawa Y, Adachi Y, Ukishima H. [A case of alpha-methyldopa-induced hemolytic anemia with cholestasis (author's transl)] Rinsho Ketsueki 1977; 18: 821-7. Japanese. PMID: 916211
Sotaniemi EA, Hokkanen OT, Ahokas JT, Pelkonen RO, Ahlqvist J. (1977). Hepatic injury and drug metabolism in patients with alpha-methyldopa-induced liver damage. Eur J Clin Pharmacol. (Summary of 36 cases of methyldopa hepatotoxicity, 14 with acute presentation with hepatocellular or mixed injury and jaundice within 1-6 months and 22 with chronic onset, often insidiuous, injury usually mixed and anicteric arising within 12-24 months of starting; 4 cases occurred in one family).
Thomas E, Rosenthal WS, Zapiach L, Micci D. (1977). Spectrum of methyldopa liver injury. Am J Gastroenterol. (Seven cases of methyldopa hepatotoxicity with hepatocellular injury and jaundice occurring 6-12 weeks after starting methyldopa, only one with autoantibodies, one fatal, all jaundiced).
Furhoff AK. (1978). Adverse reactions with methyldopa--a decade's reports. Acta Med Scand. (Summary of 75 Swedish adverse event reports on methyldopa between 1966-75; fever in 166 [latency usually <3 weeks], hemolysis 67 [2 months to years], liver injury 29 [1 month to years], allergic reactions 23, gastrointestinal 17, psychiatric 13, other 27; those with fever often had mild ALT elevations).
Hokkanen OT, Sotaniemi EA. (1978). Liver injury and multiple drug therapy. Arch Toxicol Suppl. (Description of 100 cases of drug induced liver injury presenting over 10 year period to one Finnish center; 36 due to sulphonamides, 16 nitrofurantoin, 20 contraceptives, 10 methyldopa [10%]).
Delpre G, Grinblat J, Kadish U, Livni E, Shoha B. Case report. Immunological studies in a case of hepatitis following methyldopa administration. Am J Med Sci 1979; 277: 207-13. PMID: 37733 (55 year old woman developed acute hepatitis 7 days after starting methyldopa [bilirubin 6.8 mg/dL, AST 858 U/L, Alk P 214 U/L], with concurrent autoantibodies, ANA disappeared after stopping but SMA remained present; extensive immunologic tests also performed).
Seggie J, Saunders SJ, Kirsch RE, Campbell JAH, Gitlin N, Clain D, Terblanche J. (1979). Patterns of hepatic injury induced by methyldopa. S Afr Med J. (12 patients with methyldopa hepatotoxicity, 9 with acute hepatocellular disease and jaundice with onset in 1-9 weeks, of whom 2 died; 3 patients developed chronic disease arising after 1-7 years of therapy accompanied by mild jaundice and ALT elevations, one not fully resolving by 8 months after stopping).
Shashaty GG. (1979). Cryptogenic cirrhosis associated with methyldopa. South Med J. (55 year old woman presented with ascites and cryptogenic cirrhosis having been on methyldopa for 5 years, with normal ALT, AST and bilirubin; Coombs positive).
Beaugrand M, Gavillon C, Ferrier JP. [High levels of endoplasmic reticulum antibody titer in a case of alpha-methyldopa-induced chronic active hepatitis (author's transl)] Gastroenterol Clin Biol 1980; 4: 219-21. French. PMID: 7380145
Arranto AJ, Sotaniemi EA. (1981). Morphologic alterations in patients with alpha-methyldopa-induced liver damage after short- and long-term exposure. Scand J Gastroenterol. (Comparison of 7 patients with acute icteric hepatitis after short term [3-6 months] and 24 with chronic usually anicteric hepatitis after long term [3-11 years] methyldopa; histology showed fat and some fibrosis in chronic cases, but also showed chronic hepatitis).
Arranto AJ, Sotaniemi EA. (1981). Histologic follow-up of alpha-methyldopa-induced liver injury. Scand J Gastroenterol. (Follow up liver biopsies in 6 patients with chronic methyldopa injury, 7-24 months later; resolution of enzyme elevations and clinical improvement occurred, but liver biopsies showed persistence of of fat and fibrosis, one patient developed cirrhosis).
Balázs M, Kovách G. (1981). Chronic aggressive hepatitis after methyldopa treatment. Case report with electron-microscopic study. Hepatogastroenterology. (52 year old woman developed liver injury 4 months after starting methyldopa, which resolved rapidly upon stopping and recurred within 3 weeks of reexposure [bilirubin 0.9 mg/dL, ALT 354 U/L, Alk P 2 times ULN]; biopsy suggested chronic active hepatitis).
Bezahler GH. (1982). Fatal methyldopa-associated granulomatous hepatitis and myocarditis. Am J Med Sci. (78 year old woman developed drug fever after years of methyldopa therapy, sudden death and autopsy showed granulomatous myocarditis, many granulomas in liver and elsewhere, minimal ALT elevation and no jaundice, indicative of drug fever with systemic granulomas).
Breland BD, Hicks GS. (1982). Hepatitis and hemolytic anemia associated with methyldopa therapy. Drug Intell Clin Pharm. (56 year old man presented with jaundice after 7 years of methyldopa therapy [bilirubin 41 mg/dL, AST 105 U/L, Alk P 122 U/L, ANA negative, Coombs positive]; liver biopsy showed cirrhosis with slow and incomplete recovery and associated hemolytic anemia that resolved more rapidly upon stopping).
Dossing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Review of 572 Danish cases of drug induced liver injury between 1968-78, methyldopa accounted for 11 cases, 8 with acute and 3 with chronic presentations).
Seeverens H, de Bruin CD, Jordans JG. (1982). Myocarditis and methyldopa. Acta Med Scand. (Autopsy series of 6 patients who died suddenly due to granulomatous myocarditis while receiving methyldopa [for 16 days to 3 years], most also had granulomas in liver or chronic hepatitis; no clinical information).
Orozco López P, Romá¡n Martínez J, Sorribes Puelles R, Trilla Soler M, Pujol Fernández C. [Carbamazepine and methyldopa: a hepatotoxic combination?] Med Clin (Barc) 1983; 81: 40-1. Spanish. PMID: 6888059
Shalev O, Mosseri M, Ariel I, Stalnikowicz R. (1983). Methyldopa-induced immune hemolytic anemia and chronic active hepatitis. Arch Intern Med. (76 year old man developed mild hepatitis [bilirubin 2.1 mg/dL, ALT 205 U/L] and hemolytic anemia after 3 years of methyldopa therapy [Coombs positive, SMA positive]; delayed recovery on stopping methyldopa, but rapid response to prednisone and no recurrence upon withdrawal).
Neuberger J, Kenna JG, Nouri Aria K, Williams R. (1985). Antibody mediated hepatocyte injury in methyl dopa induced hepatotoxicity. Gut. (9 cases of methyldopa hepatotoxicity; 5 with acute liver failure, 3 acute self-limited hepatitis, 1 chronic active hepatitis arising 7 weeks to 3 years after starting methyldopa; 5 had antibody mediated cytotoxicity to rabbit hepatocytes exposed to methyldopa and a microsomal enzyme inducer).
Otsuka M, Fujimura M, Koshino T, Ueda M, Otake S, Funada H, Harada M, et al. [A case of autoimmune hemolytic anemia, interstitial pneumonia and liver injury occurred during one month's medication of small dose of alpha-methyldopa] Rinsho Ketsueki 1985; 26: 1647-53. Japanese. PMID: 4094082
Sakurai S, Yamada S, Nagamine T, Takezawa J, Ichikawa K, Arai T, Takagi H, et al. [A male case of methyldopa-induced liver injury with positive lupus cell preparation] Nippon Shokakibyo Gakkai Zasshi 1985; 82: 2134-8. Japanese. PMID: 2419608
Minakami H, Ohkusa T, Kimura K, Tamada T, Hirota N. [Hepatic injury caused by methyldopa in a pre-eclamptic patient] Nippon Sanka Fujinka Gakkai Zasshi 1986; 38: 139-42. Japanese. PMID: 3950462
Rao KV. (1986). Cholestatic jaundice associated with methyldopa. Minn Med. (40 year old man with probable alcoholic liver disease developed jaundice and cholestatic pattern of enzymes 2-3 months after restarting methyldopa [bilirubin 17.5 mg/dL, AST 60 U/L, Alk P 5 times ULN], resolving rapidly upon stopping).
Stanley P, Mijch A. (1986). Methyldopa: an often overlooked cause of fever and transient hepatocellular dysfunction. Med J Aust. (Summary of 78 cases of methyldopa induced fever, onset in 5-35 days, no rash or eosinophilia, often have mild ALT elevations [~61%], occasionally hepatitis with jaundice [18%]).
Olmos M, Guma C, Colombato LO, Lami G, Miyashiro R, Alvarez E. [Hepatic lesions induced by drugs. Report of 26 cases] Acta Gastroenterol Latinoam 1987; 17: 105-11. Spanish. PMID: 3442185
Lee WM, Denton WT. (1989). Chronic hepatitis and indolent cirrhosis due to methyldopa: the bottom of the iceberg?. J S C Med Assoc. (Among 15 cases of drug induced liver disease seen over a 2.5 year period, 6 were were due to methyldopa, including 2 with an acute [bilirubin 11-13 mg/dL, AST 500-1700 U/L, Alk P 247-345 U/L] and 4 a chronic presentation [bilirubin 0.3-3.1 mg/dL, AST 39-545 U/L, Alk P 121-280 U/L], all with SMA positivity, 3 presenting with cirrhosis [on methyldopa for 4-9 years]).
Lee MG, Hanchard B, Williams NP. (1989). Drug-induced acute liver disease. Postgrad Med J.
Moses A, Zahger D, Amir G. (1989). Cholestatic liver injury after prolonged exposure to methyldopa. Digestion. (75 year old man developed jaundice having been on methyldopa for 6 years [bilirubin 26.3 mg/dL, ALT 960 U/L, Alk P 1120 U/L], resolving within 5 months of stopping).
Picaud A, Walter P, de Préville G, Nicolas P. [Fatal toxic hepatitis in pregnancy. A discussion of the role of methyldopa] J Gynecol Obstet Biol Reprod (Paris) 1990; 19: 192-6. French. PMID: 2324442
Mirada Canals A, Monteagudo Jimenez M, Sole Villa J, Rodriguez Moreno C. (1991). Methyldopa-induced granulomatous hepatitis. DICP.
Friis H, Andreasen PB. (1992). Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med. (Among 1100 liver adverse event reports in Denmark, methyldopa accounted for 13, ranking 17th).
Daghfous R, el Aidli S, Loueslati MH, Sakka T, Takhal M, Ben Mami N, Ben Khelifa H, et al. [Methyldopa-induced hepatitis: 3 case reports] Tunis Med 1994; 72: 47-50. French. PMID: 8203031
Smith GN, Piercy WN. (1995). Methyldopa hepatotoxicity in pregnancy: a case report. Am J Obstet Gynecol. (30 year old woman developed jaundice 3 weeks after starting methyldopa during pregnancy [bilirubin 6.6 mg/dL, ALT 2415 U/L], with slow recovery and then recurrence with reexposure).
Pillans PI. (1996). Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J. (Adverse event reporting over 20 year period from New Zealand identified 943 liver injuries from medications; top 10 drugs included methyldopa [n=38], which decreased in ranking from 3rd [before 1980] to 4th [1980-87] to <20th [1988-94]).
Lammert F, Matern S. [Hepatic diseases caused by drugs] Schweiz Rundsch Med Prax 1997; 86: 1167-71. German. PMID: 9333916
Thomas LA, Cardwell MS. (1997). Acute reactive hepatitis in pregnancy induced by alpha-methyldopa. Obstet Gynecol. (37 year old woman developed jaundice with hepatocellular pattern of enzymes 9 weeks after starting methyldopa therapy during pregnancy [bilirubin 13.9 mg/dL, ALT 898 U/L, Alk P 95 U/L], resolving within 4 weeks of stopping).
Follmann M, Heinemann LA, Bauerfeind A, Garbe E. (2000). Treatment with potentially hepatotoxic drugs and the risk of hepatocellular carcinoma: results of a european case - control study. Pharmacoepidemiol Drug Saf. (Case control study of 317 cases of hepatocellular carcinoma found no association of cancer with taking medications including methyldopa).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Reports to a Spanish network identified 570 cases of drug induced liver disease between 1994-2005, methyldopa not mentioned).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified, but only one was attributed to methyldopa).
Fernández-Marcote Menor EM, Pérez-Bedmar Delgado J. [Methyldopa-induced acute toxic hepatitis] Rev Esp Enferm Dig 2005; 97: 840-1. Spanish. PMID: 16438629 (43 year old woman was given methyldopa during pregnancy and developed jaundice when she continued it afterwards [bilirubin 11 mg/dL, ALT 1904 U/L, ANA positive], resolving within 6 weeks of stopping).
Phadnis SV, Sangay MR, Sanusi FA. (2006). Alpha-methyldopa-induced acute hepatitis in pregnancy. Aust N Z J Obstet Gynaecol. (40 year old woman developed fatigue within 2 weeks and jaundice within 4 weeks of starting methyldopa during pregnancy [bilirubin 2.0-5.4 mg/dL, ALT 2511 U/L, Alk P 216 U/L, ANA 1:180], resolving within 6 weeks of stopping).
Podymow T, August P. (2007). Hypertension in pregnancy. Adv Chronic Kidney Dis. (Guidelines to therapy of hypertension during pregnancy).
Abalos E, Duley L, Steyn DW, Henderson-Smart DJ. (2007). Antihypertensive drug therapy for mild to moderate hypertension during pregnancy. Cochrane Database Syst Rev. (Treatment of mild-to-moderate hypertension during pregnancy has little effect on outcomes; beta blockers are more effective than methyldopa in reducing blood pressure).
Yusuff KB, Ajayi A, Joseph YB. (2008). Laboratory monitoring of hematological and hepatic parameters in ambulatory patients receiving alpha-methyldopa in a Nigerian tertiary care setting. Curr Drug Saf. (Retrospective chart review of whether ALT and AST monitoring was done in 260 patients given methyldopa; found no testing performed during first 6-12 weeks of therapy).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 5 cases were attributed to methyldopa).
Ali T, Srinivasan N, Le V, Rizvi S. (2009). Alpha-methyldopa hepatotoxicity in pregnancy. J Coll Physicians Surg Pak. (33 year old woman developed jaundice 6 weeks after starting methyldopa during pregnancy [bilirubin 19.9 mg/dL, ALT 1303 U/L, Alk P 134 U/L, ANA negative], resolving rapidly with prednisone treatment).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 2 due to methyldopa).
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, Lindor K. (2010). Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology. (Retrospective analysis of 261 cases of autoimmune hepatitis, 24 [9%] of which were due to a medication; 11 nitrofurantoin and 11 minocylcine, but none due to methyldopa; drug induced cases resembled idiopathic cases in all regards except in ability to stop corticosteroids without relapse).
Ozsvár Z, Solymossi Z, Monostory K. [Methyldopa-induced acute reactive hepatitis in pregnancy, drug-metabolizing capacity of the liver]. Orv Hetil 2010; 151: 457-61. Hungarian. PMID: 20211808 (A 35 year old pregnant woman developed hepatitis at gestational week 23 [bilirubin 6.1 mg/dL, ALT 1190 U/L, Alk P 266 U/L, ANA negative], resolving rapidly on stopping methyldopa therapy).
Ozaslan E. (2011). Drug-induced autoimmune hepatitis: an easily reversible type of liver fibrosis?. Hepatology. (Letter in response to Björnsson [2010] discussing the reversibility of early fibrosis in cases of drug induced autoimmune hepatitis).
Slim R, Ben Salem C, Hmouda H, Bouraoui K. (2010). Hepatotoxicity of alpha-methyldopa in pregnancy. J Clin Pharm Ther. (A 34 year old woman developed jaundice and pruritus 4 weeks after starting methyldopa during pregnancy [bilirubin 9.4 mg/dL, ALT 685 U/L, Alk P 301 U/L], resolving within 10 weeks of stopping).
Czaja AJ. (2011). Drug-induced autoimmune-like hepatitis. Dig Dis Sci. (Review of drug induced autoimmune hepatitis, the principal causes being minocycline and nitrofurantoin; other causes were methyldopa, hydralazine, statins, fibrates, diclofenac, anti-TNF agents, interferons, propylthiouracil, and isoniazid).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period none of which were attributed to methyldopa or other antihypertensive medications).
deLemos AS, Foureau DM, Jacobs C, Ahrens W, Russo MW, Bonkovsky HL. (2014). Drug-induced liver injury with autoimmune features. Semin Liver Dis. (Review of autoimmune drug induced liver injury which provides an example in a 39 year old African American woman treated with methyldopa shortly after pregnancy who developed jaundice 1 month later [bilirubin 19.9 mg/dL, ALT 1869 U/L, Alk P 205 U/L, ANA positive], resolving spontaneously within 6 months of stopping methyldopa).
Kashkooli S, Baraty B, Kalantar J. (2014). α-Methyldopa-induced hepatitis during the postpartum period. BMJ Case Rep. (A 34 year old woman developed hepatitis two months after delivery and while on methyldopa [bilirubin 18.8 mg/dL, ALT 1018 U/L, Alk P 275 U/L, INR 1.2 rising to 1.7, ANA positive], resolving within 2 months of stopping drug).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, 2 were attributed to methyldopa, one of which was fatal).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. PMID: 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were attributed to antihypertensive drugs including 11 to methyldopa).
Koizumi T, Furuya K, Baba M, Sadaoka K, Sekiya C, Hattori A, Goto R, et al. [Case Report; A case of subacute fulminant hepatitis induced by methyldopa]. Nihon Naika Gakkai Zasshi 2015; 104: 586-9. Japanese. PMID: 26571747 (A 40 year old woman developed severe hepatitis while receiving methyldopa [bilirubin 18.4 mg/dL, ALT 1685 U/L, Alk P 833 U/L, INR 2.17, ANA positive], with progressive hepatic failure and death).
Firoz T, Webber D, Rowe H. (2015). Drug-induced fulminant hepatic failure in pregnancy. Obstet Med. (A 39 year old pregnant woman developed jaundice 8 weeks after starting labetalol and 4 weeks after methyldopa [bilirubin 17.8 mg/dL, ALT 1406 U/L, Alk P 159 U/L, INR 3.1, ANA positive], resolving rapidly after stopping both medications and a complicated delivery).
Stine JG, Northup PG. (2016). Autoimmune-like drug-induced liver injury: a review and update for the clinician. Expert Opin Drug Metab Toxicol. (Review of drug induced liver injury with autoimmune features discusses methyldopa as a frequent cause).
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, et al. (2017). Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol. (Among 985 patients with drug-induced liver injury enrolled in a prospective US database between 2004 and 2016, methyldopa accounted for 4% of cases among 144 African Americans compared to <1% of 841 caucasians, and disease severity and worse outcomes were more frequent in African American subjects both overall and for methyldopa).
de Boer YS, Kosinski AS, Urban TJ, Zhao Z, Long N, Chalasani N, Kleiner DE, Hoofnagle JH, Drug-Induced Liver Injury Network. (2017). Features of autoimmune hepatitis in patients with drug-induced liver injury. Clin Gastroenterol Hepatol. (Analysis of 88 cases of liver injury due to medications known to induce autoimmune markers [including methyldopa, hydralazine, nitrofurantoin and minocycline] found that clinical features were similar in those with and those without an autoimmune phenotype and that HLA Class I and II alleles associated with spontaneous autoimmune hepatitis were not increased among patients with drug induced autoimmune liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Methyldopa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=methyldopa/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Methyldopa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=methyldopa)